# Vedolizumab

## OVERVIEW

### Introduction

Vedolizumab is a humanized monoclonal antibody to integrin α4β7 which is used in the treatment of inflammatory bowel disease. Vedolizumab has been linked to a low rate of serum enzyme elevations during therapy, but has not been linked to cases of idiosyncratic, clinically apparent liver injury with jaundice. Because vedolizumab is a potent inhibitor of lymphocyte function, it may cause reactivation of chronic hepatitis B in susceptible patients.

### Background

Vedolizumab (ve” doe liz’ ue mab) is a humanized monoclonal immunoglobulin G1 antibody to integrin α4β7 (also known as lymphocyte Peyer’s patch adhesion molecule 1: LPAM-1), a cell surface molecule that plays a role trafficking inflammatory cells to sites of injury in the gastrointestinal mucosa. Vedolizumab is one of several inhibitors of integrin α4β7 that have been evaluated in autoimmune conditions. In controlled clinical trials, vedolizumab has been shown to decrease inflammation and improve symptoms in patients with refractory or relapsing inflammatory bowel disease. Vedolizumab was approved for use in the United States for both ulcerative colitis and Crohn colitis in 2014 and is recommended only for patients with moderate-to-severe inflammatory bowel disease who have not responded to corticosteroids, immunosuppressants or TNF antagonists. Vedolizumab is available as a lyophilized power in single use vials of 300 mg under the brand name Entyvio. Vedolizumab is given intravenously in a dose of 300 mg over approximately 30 minutes at 0 and 2 weeks, followed by every 4 weeks thereafter. Common side effects include injection site reactions, chills, fever, skin rash and fatigue. Less common, but potentially severe side effects include hypersensitivity reactions and anaphylaxis, opportunistic infections, reactivation of tuberculosis or hepatitis B, congestive heart failure, lymphoma and other malignancies and demyelinating diseases.

### Hepatotoxicity

In prelicensure controlled trials, rates of serum ALT elevations during vedolizumab were not reported, although instances of serum enzyme elevations were described. ALT elevations above 5 times the upper limit of normal (ULN) were said to occur in <2% of vedolizumab and in a similar proportion of placebo recipients, and only rare patients had to stop therapy because of serum enzyme elevations. In the prelicensure trials, 3 patients were reported to have a severe adverse reaction of hepatitis, but the specific details were not given. Since its approval and more widespread use, there have been a few isolated reports of liver injury occurring during vedolizumab therapy but usually in the presence of other competing causes.

However, vedolizumab is a potent immunomodulatory agent and may be capable of causing reactivation of hepatitis B. To date, however, neither vedolizumab nor natalizumab (another monoclonal antibody to integrin α4β7) have been linked to instances of reactivation of hepatitis B. Nevertheless, because of the possibility of reactivation, screening for markers of HBV infection before starting therapy is prudent. Patients with HBsAg or anti-HBc in serum should be monitored for evidence of reactivation and treated promptly with antiviral therapy if HBV DNA or HBsAg appear.

Finally, vedolizumab may reactivate other viral infections and acute hepatitis due to an opportunistic viral infection.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Why a monoclonal antibody would cause hepatic injury is unclear. The mechanism of liver injury in reactivation of hepatitis B appears to be a brisk immunological response to newly expressed viral antigens. Injury generally arises after the immunosuppressive therapy has stopped or between courses of treatment.

### Outcome and Management

Current guidelines for management of patients who are to receive vedolizumab do not recommend routine screening for hepatitis B before starting treatment. If screening is planned, it should include tests for HBsAg and anti-HBc (and perhaps also anti-HBs as this may help in management). An appropriate approach for patients with markers of hepatitis B is careful monitoring for HBV DNA during therapy and early institution of antiviral therapy if levels rise. While reactivation of tuberculosis has been reported after vedolizumab therapy, instances of reactivation of hepatitis B have not, although experience with the agent has been limited and patients with preexisting hepatitis B were typically excluded from prelicensure studies.

Drug Class: Gastrointestinal Agents, Inflammatory Bowel Disease Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vedolizumab – Entyvio®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Vedolizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vedolizumab | 943609-66-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2020

Abbreviations: IBD, inflammatory bowel disease; PSC, primary sclerosing cholangitis.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 944-54. (Textbook of pharmacology and therapeutics).
Feagan BG, Greenberg GR, Wild G, Fedorak RN, Paré P, McDonald JW, Cohen A, et al. (2008). Treatment of active Crohn's disease with MLN0002, a humanized antibody to the alpha4beta7 integrin. Clin Gastroenterol Hepatol. (Among 123 patients with Crohn disease treated with vedolizumab [0.5 or 2.0 mg/kg] or placebo in two infusions 4 weeks apart, response rates were marginally higher with vedolizumab [49% and 53% vs 41%], but adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Baumgart DC. (2010). Veto on vedolizumab (MLN0002) for Crohn's disease. Inflamm Bowel Dis. (Summary of results of the phase 2 trial of vedolizumab [Feagan 2008] and commentary raising issues of marginal efficacy and concerns over safety).
Parikh A, Leach T, Wyant T, Scholz C, Sankoh S, Mould DR, Ponich T, et al. (2012). Vedolizumab for the treatment of active ulcerative colitis: a randomized controlled phase 2 dose-ranging study. Inflamm Bowel Dis. (Among 47 patients with ulcerative colitis treated with vedolizumab in 3 different doses [2, 6 or 10 mg/kg] or placebo in four infusions at weeks 0, 2, 4 and 12, there were "no clinically significant changes in laboratory parameters", but one patient had an abnormal ALT level at week 2 [137 U/L] that resolved by week 4 and did not increase thereafter with further therapy).
Parikh A, Fox I, Leach T, Xu J, Scholz C, Patella M, Feagan BG. (2013). Long-term clinical experience with vedolizumab in patients with inflammatory bowel disease. Inflamm Bowel Dis. (Among 72 patients with ulcerative colitis or Crohn disease treated with vedolizumab in maintenance doses of 2, 6 or 10 mg/kg every 8 weeks for up to 3 years, serious adverse events included infections, but neither ALT abnormalities nor instances of hepatotoxicity were reported).
Sandborn WJ, Feagan BG, Rutgeerts P, Hanauer S, Colombel JF, Sands BE, Lukas M, et al. (2013). GEMINI 2 Study Group. Vedolizumab as induction and maintenance therapy for Crohn's disease. N Engl J Med. (Among 1115 patients with Crohn disease in controlled trials, clinical remissions were more frequent with intravenous vedolizumab than placebo at week 6 [14.5% vs 7%] and week 52 [36-39% vs 22%], but rates of infections including serious infections were also increased; no mention of ALT elevations or hepatotoxicity).
Feagan BG, Rutgeerts P, Sands BE, Hanauer S, Colombel JF, Sandborn WJ, Van Assche G, et al. (2013). GEMINI 1 Study Group. Vedolizumab as induction and maintenance therapy for ulcerative colitis. N Engl J Med. (Among 895 patients with ulcerative colitis in two placebo controlled trials, response rates were more frequent with intravenous vedolizumab than placebo at week 6 [47% vs 26%] and week 42 [42-45% vs 16%], and side effects rates were similar with "no significant differences in... liver-function test results").
Cominelli F. (2013). Inhibition of leukocyte trafficking in inflammatory bowel disease. N Engl J Med. (Editorial in response to Sandborn and Feagan 2013).
Danese S, Fiorino G, Peyrin-Biroulet L, Lucenteforte E, Virgili G, Moja L, Bonovas S. (2014). Biological agents for moderately to severely active ulcerative colitis: a systematic review and network meta-analysis. Ann Intern Med. (Systematic review of biologic agents for ulcerative colitis gives overall rates of adverse events, but not specifics and does not mention ALT elevations, hepatotoxicity or reactivation of hepatitis B).
Sands BE, Feagan BG, Rutgeerts P, Colombel JF, Sandborn WJ, Sy R, D'Haens G, et al. (2014). Effects of vedolizumab induction therapy for patients with Crohn's disease in whom tumor necrosis factor antagonist treatment failed. Gastroenterology. (Among 416 patients with Crohn disease who had failed to respond adequately to anti-TNF agents, response rates were no higher with vedolizumab compared to placebo therapy [15% vs 12%] and rates of adverse events, including infections, were similar; no mention of ALT elevations or hepatotoxicity).
(2014). Vedolizumab (Entyvio) for inflammatory bowel disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and cost of vedolizumab therapy in ulcerative colitis and Crohn disease shortly after its approval for this indication in the US; adverse events include hypersensitivity reactions, anaphylaxis, increased risk of infection, and increased "transaminases and bilirubin levels have been reported").
Stine JG, Wang J, Behm BW. (2016). Chronic cholestatic liver injury attributable to vedolizumab. J Clin Transl Hepatol. (23 year old man with ulcerative colitis developed jaundice after a 3rd dose of vedolizumab [bilirubin 13.3 mg/dL, ALT 27, AST 52, Alk P 370 U/L], liver enzymes being minimally increased from the elevated levels present before treatment and jaundice persisting for 4-5 months after stopping the monoclonal antibody).
Lim TY, Pavlidis P, Gulati S, Pirani T, Samaan M, Chung-Faye G, Dubois P, et al. (2016). Vedolizumab in inflammatory bowel disease associated with autoimmune liver disease pre- and post-liver transplantation: a case series. Inflamm Bowel Dis. (Case series of 10 patients with PSC and IBD who were treated with vedolizumab for 1-13 months with remissions in the IBD in 4 and no hepatobiliary complications).
Christensen B, Micic D, Gibson PR, Yarur A, Bellaguarda E, Corsello P, Gaetano JN, et al. (2018). Vedolizumab in patients with concurrent primary sclerosing cholangitis and inflammatory bowel disease does not improve liver biochemistry but is safe and effective for the bowel disease. Aliment Pharmacol Ther. (Analysis of 34 adults with IBD and PSC who were treated with vedolizumab for an average of 9 months, there were no significant changes in Alk P, ALT or bilirubin and one patient with normal liver enzymes at baseline developed an Alk P of 351 U/L and ALT of 264 U/L, which returned to normal 3 months after stopping vedolizumab).
Pavlidis P, Graham J, Gulati S, Dubois P, Heneghan M, Joshi D, Hayee B. (2018). Letter: vedolizumab for autoimmune liver disease associated inflammatory bowel disease. Aliment Pharmacol Ther. (In response to Christensen [2018], the authors mention that among 17 patients with IBD and PSC who were treated with vedolizumab there was no improvement in liver biochemistry results and 2 patients developed colorectal cancer).
Christensen B, Gibson PR, Rubin DT. (2018). Letter: vedolizumab for autoimmune liver disease associated inflammatory bowel disease-Authors' reply. Aliment Pharmacol Ther. (In response to letter from Pavlidis [2018], the authors mention that they have had no instance of colorectal cancer but have had 3 serious hepatic adverse events among the 34 patients with IBD and PSC who received vedolizumab).
Lenti MV, Levison S, Eliadou E, Willert R, Kemp K, Carter A, Stansfield C, et al. (2018). A real-world, long-term experience on effectiveness and safety of vedolizumab in adult patients with inflammatory bowel disease: The Cross Pennine study. Dig Liver Dis. (Among 203 patients with IBD treated in UK medical centers between 2014 and 2018, 128 had a sustained clinical response at 2 weeks, while adverse events included elevated liver tests in 2 patients; no details provided).
Kapila N, Flocco G, Shen B, Modaresi Esfeh J. (2018). The use of vedolizumab in patients with concomitant cirrhosis and Crohn's disease. Cureus. (Three patients with Crohn disease and cirrhosis [autoimmune hepatitis, hepatitis C and cryptogenic] were treated with vedolizumab and all three had a clinical response and none had worsening of the liver disease or decompensation after 5, 32 and 36 months of the monoclonal antibody).
Kopylov U, Avni-Biron I, Ron Y, Koslowsky B, Waterman M, Daher S, Ungar B, et al. (2019). Effectiveness and safety of vedolizumab for maintenance treatment in inflammatory bowel disease-The Israeli real world experience. Dig Liver Dis. (Among 193 patients with IBD from 9 centers in Israel who were treated with vedolizumab, the 52 week response rate was approximately 50% and only 18 patients had adverse events; no mention of ALT elevations or hepatotoxicity).
Kopylov U, Verstockt B, Biedermann L, Sebastian S, Pugliese D, Sonnenberg E, Steinhagen P, et al. (2018). Effectiveness and safety of vedolizumab in anti-TNF-naïve patients with inflammatory bowel disease-a multicenter retrospective European study. Inflamm Bowel Dis. (Among 184 patients with IBD treated with vedolizumab at 23 European enters, the remission rate ranged from 64-68% and only 20 patients [11%] had adverse events including one with cholestasis and one undergoing liver transplantation ).
Spadaccini M, Aghemo A, Caprioli F, Lleo A, Invernizzi F, Danese S, Donato MF. (2019). Safety of vedolizumab in liver transplant recipients: A systematic review. United European Gastroenterol J. (Systematic review of safety of vedolizumab in liver transplant recipients identified 31 patients among whom 23% developed an infection and 1 patient had an episode of acute rejection, but no patient died and 77% had a clinical response in IBD activity).
Caron B, Peyrin-Biroulet L, Pariente B, Bouhnik Y, Seksik P, Bouguen G, Caillo L, et al. (2019). Vedolizumab therapy is ineffective for primary sclerosing cholangitis in patients with inflammatory bowel disease: a GETAID multicentre cohort study. J Crohns Colitis. (Among 75 patients with IBD and PSC treated with vedolizumab at 22 medical centers for at least 30 weeks, there was no significant change in serum enzyme levels during extended treatment averaging 19 months, 7 patients developed colorectal cancer and 2 cholangiocarcinoma).
Lynch KD, Chapman RW, Keshav S, Montano-Loza AJ, Mason AL, Kremer AE, Vetter M, et al. (2020). International Primary Sclerosing Cholangitis Study Group (IPSCSG), Levy C. Effects of vedolizumab in patients with primary sclerosing cholangitis and inflammatory bowel diseases. Clin Gastroenterol Hepatol. (Among 102 patients with IBD and PSC treated with vedolizumab and followed for an average of 412 days, serum Alk P, ALT and bilirubin levels increased slightly [by 10% to 20%] and liver related adverse events occurred in 22 patients, including new onset ascites [n=6], cholangitis [n=9] and liver transplantation [n=8], but no patient died or developed cholangiocarcinoma).

## OTHER REFERENCE LINKS

1 Recent References on Vedolizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vedolizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Vedolizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vedolizumab)